# Carbonic Anhydrase Inhibitors

## OVERVIEW

### Introduction

Acetazolamide and methazolamide are carbonic anhydrase inhibitors used as diuretics and in the therapy of glaucoma. Both acetazolamide and methazolamide have been linked to rare cases of clinically apparent drug induced liver disease.

### Background

Acetazolamide (a seet" a zol' a mide) and methazolamide (meth" a zol' a mide) are inhibitors of carbonic anhydrase, an enzyme that converts carbon dioxide and water to carbonic acid. Inhibition of this enzyme in the kidney causes an alkalization of the urine and diuresis. In the eye, inhibition of carbonic anhydrase causes a decrease in intraocular pressure making these agents valuable in the treatment of glaucoma. The effects of acetazolamide on acid-base status (causing a mild metabolic acidosis) are also of potential value in managing other conditions including epilepsy, sleep apnea, and acute mountain sickness. Acetazolamide was approved for use in the United States in 1986 for treatment of glaucoma and as a diuretic to prevent or ameliorate acute mountain sickness. Acetazolamide is available in 125 and 250 mg tablets in generic forms and under the brand name of Diamox. Acetazolamide is also available in extended release forms (capsules of 500 mg) and as powder for injection. The recommended dose and regimen of acetazolamide varies by indication, but for chronic use in adults the typical dose is 250 to 1,000 mg daily in divided doses.

Methazolamide was approved for use in the United States in 1959 for the treatment of glaucoma. Methazolamide is available as tablets of 25 and 50 mg in generic forms and under the trade name Neptazane. Typical doses of methazolamide in adults with glaucoma are 50 to 100 mg two to three times daily.

The common side effects of acetazolamide and methazolamide are change in taste, numbness and tingling in fingers and toes, blurred vision, tinnitus, dizziness, decrease in hearing, polyuria, nausea, diarrhea, fatigue, and headache. Methazolamide and acetazolamide have similar chemical structures and are related to the sulfonamides and can cause allergic reactions including anaphylaxis, rash, erythema multiforme, and Stevens Johnson syndrome.

### Hepatotoxicity

Idiosyncratic, clinically apparent liver injury from acetazolamide and methazolamide is rare, but several instances have been reported as isolated case reports. Acetazolamide is a sulfonamide and cross reactivity to sulfonamide reactions have been reported. The liver injury typically arises after a few days to weeks of therapy and the pattern of serum enzyme elevations is usually hepatocellular or mixed. Immunoallergic features (rash, fever, eosinophilia) are common, but autoantibody formation is not. Both acetazolamide and methazolamide have been linked to Stevens Johnson syndrome and a genetic association has been made with HLA-B*59:01. Hepatic involvement and jaundice can occur in cases of Stevens Johnson syndrome but is generally overshadowed by the severe cutaneous reaction.

Likelihood score: D (possible but rare cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism of acetazolamide hepatic injury is believed to be due to hypersensitivity with shared pathogenesis with the sulfonamides.

### Outcome and Management

Severity ranges from mild, asymptomatic elevations in serum enzymes, to clinically apparent acute hepatitis to severe injury with acute liver failure or prolonged jaundice. Corticosteroids are often used in patients with other features of hypersensitivity, but their role in altering the ultimate outcome of the injury is unproven. Rechallenge should be avoided and patients should be warned to avoid sulfa-containing drugs in the future.

Drug Class: Diuretics

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Acetazolamide – Generic, Diamox®

Methazolamide – Generic, Neptazane®

DRUG CLASS

Diuretics

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Acetazolamide) (Acetazolamide)

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Methazolamide) (Methazolamide)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Acetazolamide | 59-66-5 | C4-H6-N4-O3-S2
Methazolamide | 554-57-4 | C5-H8-N4-O3-S2

## ANNOTATED BIBLIOGRAPHY

References updated: 13 October 2021

Zimmerman HJ. Diuretic drugs. Drugs used in cardiovascular disease. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 662-4. (Expert review of hepatotoxicity of diuretics published in 1999 mentions that clinically apparent liver injury due to diuretics is rare; acetazolamide and methazolamide have been linked to several instances of cholestatic or mixed hepatitis, perhaps due to hypersensitivity).
De Marzio DH, Navarro VJ. Hepatotoxicity of cardiovascular and antidiabetic drugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 519-40. (Review of hepatotoxicity of cardiovascular agents, mentions that diuretics can rarely cause cholestatic hepatitis).
Jackson EK. Drugs affecting renal excretory function. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 445-70. (Textbook of pharmacology and therapeutics).
Kristinsson A. (1967). Fatal reaction to acetazolamide. Br J Ophthalmol. (34 year old man with glaucoma developed fatigue, nausea and generalized rash followed by delirium 26 days after starting acetazolamide [bilirubin 10.9 mg/dL, ALT 180 U/L, Alk P 3 times ULN], with progressive hepatic failure and death within 24 hours).
Gangitano JL, Foster SH, Contro RM. (1978). Nonfatal methazolamide-induced aplastic anemia. Am J Ophthalmol. (83 year old man developed aplastic anemia 3 months after starting methazolamide for glaucoma; no mention of liver test abnormalities).
Werblin TP, Pollack IP, Liss RA. (1979). Aplastic anemia and agranulocytosis in patients using methazolamide for glaucoma. JAMA. (Two cases of aplastic anemia, 1 of which occurred after starting methazolamide; no mention of liver injury).
Krivoy N, Ben-Arich Y, Carter A, Alroy G. (1981). Methazolamide induced hepatitis and pure RBC aplasia. Arch Intern Med. (69 year old man with glaucoma developed rash 3 weeks after starting methazolamide with fever, diarrhea, pruritus and jaundice [bilirubin 24 mg/dL, AST 72 U/L, Alk P 865 U/L], developing anemia during recovery, resolving fully after prednisone therapy).
Sud RN, Grewal SS. (1981). Stevens Johnson syndrome due to Diamox. Indian J Ophthalmol. (Short report of Stevens Johnson syndrome in 8 Indian patients with glaucoma treated with acetazolamide; all recovered, no mention of hepatic injury or jaundice).
Flach AJ, Smith RE, Fraunfelder FT. (1995). Stevens-Johnson syndrome associated with methazolamide treatment reported in two Japanese American women. Ophthalmology. (Two cases of Stevens Johnson syndrome in Japanese women, ages 65 and 27 years, with onset of rash and fever within 10 days of starting methazolamide for glaucoma with long term skin and corneal sequelae; no mention of ALT elevations or liver injury).
Shirato S, Kagaya F, Suzuki Y, Joukou S. (1997). Stevens-Johnson syndrome induced by methazolamide treatment. Arch Ophthalmol. (Four cases of Stevens Johnson syndrome in 3 Japanese women and 1 man, ages 30 to 47 years, with onset of fever and rash 2-8 weeks after starting methazolamide for glaucoma; all recovered; no mention of hepatic injury).
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. (2004). Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl. (Among ~50,000 liver transplants reported to UNOS between 1990 and 2002, 137 [0.5%] were done for idiosyncratic drug induced acute liver failure, none were attributed to a diuretic).
Andrade RJ, Lucena MI, Fernández MC, Pelaez G, Pachkoria K, García-Ruiz E, García-Muñoz B, et al. (2005). Drug-induced liver injury: an analysis of 461 incidences submitted to the Spanish Registry over a 10-year period. Gastroenterology. (Reports of drug induced liver injury to a Spanish network found 570 cases; diuretics not mentioned as cause).
Björnsson E, Olsson R. (2006). Suspected drug-induced liver fatalities reported to the WHO database. Dig Liver Dis. (Survey of drug induced liver fatalities reported to WHO database between 1968-2003 revealed 4690 reports [89% from the US]; no diuretic found in the 20 most commonly implicated agents).
Ogasawara K, Tomitsuka N, Kobayashi M, Komoribayashi N, Fukuda T, Saitoh H, Inoue T, et al. (2006). Stevens-Johnson syndrome associated with intravenous acetazolamide administration for evaluation of cerebrovascular reactivity. Case report. Neurol Med Chir (Tokyo). (62 year old Japanese man given single intravenous injection of acetazolamide developed Stevens Johnson syndrome 3 days later responding to prednisolone; no mention of ALT levels or jaundice).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, no case was attributed to a diuretic).
(2009). Drugs for hypertension. Treat Guidel Med Lett. (Brief overview of currently available drugs for hypertension with guidelines on their use and information on prices and toxicities).
Devarbhavi H, Dierkhising R, Kremers WK, Sandeep MS, Karanth D, Adarsh CK. (2010). Single-center experience with drug-induced liver injury from India: causes, outcome, prognosis, and predictors of mortality. Am J Gastroenterol. (Among 313 cases of drug induced liver injury seen over a 12 year period at a large hospital in Bangalore, India, none were attributed to a diuretic).
Ferrajolo C, Capuano A, Verhamme KM, Schuemie M, Rossi F, Stricker BH, Sturkenboom MC. (2010). Drug-induced hepatic injury in children: a case/non-case study of suspected adverse drug reactions in VigiBase. Br J Clin Pharmacol. (Among 624,673 adverse event reports in children between 2000 and 2006 in the WHO VigiBase, no diuretic was mentioned among the 30 most common causes of liver injury).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, of which none were attributed to a diuretic).
Kim SH, Kim M, Lee KW, Kim SH, Kang HR, Park HW, Jee YK. (2010). HLA-B*5901 is strongly associated with methazolamide-induced Stevens-Johnson syndrome/toxic epidermal necrolysis. Pharmacogenomics. (Among 5 Korean patients with methazolamide induced Stevens Johnson syndrome, all had HLA-B*5901 vs 4.1% of general population in Korea; also linked to Cw*0102 and A*2402).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, none of which were attributed to a diuretic).
Başar Ö, Başar N, Tuna Y, Yüksel H, Çoban Ş. (2013). Acetazolamide induced severe hepatotoxicity. Wien Klin Wochenschr. (44 year old woman developed jaundice 2 weeks after starting acetazolamide [bilirubin 8.9 mg/dL, ALT 492 U/L, Alk P 348 U/L, INR 1.39], worsening for 4 days and then resolving within 21 days of stopping).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America: an analysis of published reports. Ann Hepatol. (Among 176 reports of drug induced liver injury from Latin America published between 1996 and 2012, none were attributed to a diuretic).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, none were attributed to a diuretic).
(2020). Drugs for hypertension. Med Lett Drugs Ther. (Concise summary of efficacy, safety and costs of drug therapy of hypertension including the diuretics, focusing upon relative usefulness; no mention of hepatic adverse events).

## OTHER REFERENCE LINKS

1 Recent References on Carbonic Anhydrase Inhibitors: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Carbonic+Anhydrase+Inhibitors)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Carbonic Anhydrase Inhibitors: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Carbonic+Anhydrase+Inhibitors)